# Acute Hepatitis

Description. The course of illness resembles acute viral hepatitis with insidious onset, a hepatocellular pattern of injury and jaundice. Symptoms (if present) include fatigue, anorexia, nausea and right upper quadrant tenderness. Illness typically lasts 2 to 4 weeks and ultimately resolves, but severe instances can result in acute liver failure and death.

Latency to Onset. The time to onset of acute hepatitis is typically 2 to 24 weeks; unlikely after 52 weeks or before 4 days.

Symptoms. Typically, an insidious onset of fatigue and nausea, followed by anorexia, abdominal discomfort (liver pain) and then dark urine and jaundice. There may be low grade fever and transient, indefinite rash during the incubation period. Itching is typically absent early in the course, but may arise if jaundice is prolonged.

Serum Enzyme Elevations. Peak ALT rising to 800 U/L (~20 times ULN) with accompanying alkaline phosphatase <3 times ULN (<345 U/L). “Probable” cases can have ALT rising to above 400 U/L (~10 times ULN), with alkaline phosphatase <2 times ULN (<230 U/L), particularly later during the course. Serum enzyme may rise for another 5 to 10 days after the medication is stopped and then decrease promptly, typically by 50% within 30 days.

Drugs. Typical agents that cause an acute viral hepatitis like illness include isoniazid, pyrazinamide, disulfiram, fenofibrate, ephedra, greater celandine, green tea, and other herbals.

Differential Diagnosis. Diagnosis should focus on acute hepatitis A, B, C and E and reactivation of hepatitis B. Acute biliary obstruction can resemble acute hepatitis during the first days after onset. Finally, ischemic hepatitis may superficially resemble acute hepatitis, but the rapid onset and rapid recovery are distinctive.

Criteria for Definition: Elements important in diagnosis of acute hepatitis in drug induced liver injury include:

1 Hepatocellular pattern of serum enzyme elevations with ALT levels rising to above 800 U/L (>20 times ULN) and Alk P levels of less than 3 times ULN (<345 U/L) at the time of peak ALT elevation
2 Latency of 2 to 24 weeks
3 Symptoms of fatigue and/or nausea
4 Bilirubin >2.5 mg/dL
5 If liver biopsy is obtained, changes of acute hepatocellular necrosis with lobular disarray and lymphocytic infiltration with minimal or no fibrosis.

A case can be considered “probable” if the peak ALT levels are between 400 to 800 U/L (~10 to 20 times ULN) and accompanying alkaline phosphatase levels are less than 2 times ULN (<230 U/L). A case can be considered “anicteric acute viral hepatitis like” if all criteria are met, but bilirubin is between 1.2 and 2.5 mg/dL and direct bilirubin (if tested) is >0.3 mg/dL. Drug induced acute hepatitis can be accompanied by immunoallergic and autoimmune features and can lead to acute liver failure and possibly cirrhosis. Between 30% and 50% of cases of drug induced liver injury fit this phenotype of being acute viral hepatitis like. This pattern is most likely to result in acute liver failure and the mortality rate of an acute hepatitis like phenotype of drug induced liver injury is at least 10% (so called “Hy’s Law”, in reference to Dr. Hyman J. Zimmerman).

## REPRESENTATIVE CASES

### Case 1. Acute hepatitis due to isoniazid.(1)

A 66 year old Hispanic man developed nausea followed by dark urine and jaundice 6 weeks after starting isoniazid for latent tuberculosis. He had been in good health except for hypertension for which he had been taking enalapril for more than a decade. Because of a positive purified protein derivative (PPD) tuberculin skin test, he was started on a 6 month course of isoniazid [300 mg daily with pyridoxine]. Laboratory tests taken before starting therapy were normal except for a slightly raised total serum bilirubin. He remained asymptomatic until onset of nausea and indigestion during week 6 of therapy. He denied fever or rash. He had not taken any over-the-counter medications, herbals or acetaminophen. He had a history of heavy drinking but had stopped 4 years previously. Physical examination showed jaundice but no signs of chronic liver disease. Laboratory tests showed a total bilirubin of 6.3 mg/dL and marked elevations in ALT, but minimal increase in alkaline phosphatase levels (Table). Tests for hepatitis A, B and C were negative. Serum antinuclear antibody (ANA) was strongly positive (1:20,480), but smooth muscle antibody was negative, and immunoglobulin levels were normal. Liver imaging showed no evidence of biliary obstruction. Liver biopsy was not done. Isoniazid was promptly stopped and he began to improve within days. Enalapril was restarted, but therapy for latent tuberculosis was not pursued. One month later, he was asymptomatic and liver tests had returned to baseline.

#### Key Points

Medication: | Isoniazid (300 mg daily)
Pattern: | Hepatocellular (R=45.9)
Severity: | 2+ (jaundice, but not hospitalized)
Latency: | 6 weeks
Recovery: | 4 weeks
Other medications: | Enalapril (chronically), pyridoxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 29 | 71 | 1.7
0 | | Isoniazid (300 mg daily) started
6 weeks | 0 | 2326 | 114 | 6.3 | Isoniazid stopped
| 1 day | 2486 | 137 | 9.0 | INR=1.2
| 4 days | 1836 | 113 | 9.5
7 weeks | 1 week | 773 | 104 | 6.1
2 months | 2 weeks | 199 | 80 | 2.6
3 months | 5 weeks | 32 | 64 | 1.3
Normal Values | | <56 | <130 | <1.2

#### Comment

Isoniazid hepatotoxicity typically presents like acute viral hepatitis with a prodrome of fatigue, nausea, poor appetite and right upper quadrant pain, followed by dark urine and jaundice, arising 4 to 24 weeks after starting therapy. Symptoms and signs may worsen for a few days after stopping isoniazid, but then usually improve rapidly. Immunoallergic features are unusual and, if present, are mild. Isoniazid therapy can induce ANA reactivity, but autoantibodies titers are usually low (making this case somewhat atypical) and not associated with other features that would suggest autoimmune hepatitis. Age above 35 years is the single major risk factor for isoniazid hepatitis. Alcohol use may also be a risk factor, but it is not clear whether the risk is related to concurrent use or with an alcohol history (probably the former). Treatment of latent tuberculosis in persons over the age of 35 should be done with caution. Patients should be informed of the risk of liver injury and warned of the signs and symptoms of liver injury. Routine biochemical monitoring is prudent if there is preexisting liver disease or perceived increased risk for liver injury. The mortality rate of isoniazid hepatitis with jaundice is at least 10%.

### Case 2. Acute hepatitis due to fenofibrate therapy.(2)

A 74 year old woman developed jaundice having been on oral therapy with fenofibrate (200 mg daily) for two years. She was not taking other medications and had no history of liver disease, alcohol use, or exposures to hepatitis. On hospital admission, physical examination revealed jaundice but no fever or rash. Laboratory findings included marked elevations in serum aminotransferase levels (Table) and bilirubin of 4.7 mg/dL. Tests for hepatitis A and B were negative, as were autoantibodies. Abdominal ultrasound and endoscopic retrograde cholangiopancreatography showed no evidence of biliary obstruction. During the first week in the hospital, serum bilirubin rose to 13.3 mg/dL and prothrombin time decreased to 46% of normal. At this point, fenofibrate was stopped and she then began to improve, with rapid regression of jaundice, allowing her to be discharged after 25 days in the hospital. In follow up over the next year, her abnormal liver tests returned to normal.

#### Key Points

Medication: | Fenofibrate (200 mg daily)
Pattern: | Hepatocellular (R=12)
Severity: | 4+ (jaundice, hospitalization, prolongation of prothrombin time)
Latency: | 2 years
Recovery: | 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
| | Started on fenofibrate for hyperlipidemia
2 years | 0 | 1430 | 142 | 4.6 | Alk P=315 (6 fold elevated)
+7 days | 0 | 900 | 160 | 12.5
+10 days | 0 | 800 | 160 | 13.3 | Fenofibrate stopped
| 4 days | 540 | 200 | 12.8
| 8 days | 400 | | 11.3
| 12 days | 440 | | 8.8
| 1 month | | 23 | 4.3
| 2 months | | 30 | 0.7
Normal Values | | <20 | <25 | <1.2

#### Comment

This patient developed a fairly severe, acute hepatitis while on long term fenofibrate therapy. The long latency to onset of injury was unusual, and initially her physicians did not think that the fenofibrate was the cause. Because of worsening jaundice over the next 10 days, however, the role of fenofibrate was reconsidered and it was stopped, whereupon she began to improve. The hepatic injury was severe and associated with prolongation of prothrombin time and worsening liver function tests. Liver biopsy was not performed and tests for hepatitis C were not available. Nevertheless, fenofibrate is a known cause of an acute hepatitis like syndrome and was probably the cause of this acute injury.

### Case 3. Acute hepatitis after using weight loss supplement.(3)

A 37 year old woman developed nausea, abdominal pain and jaundice 4 months after starting a weight loss supplement called The Right Approach Complex (Pharmanex, Provo, Utah), the major component of which was green tea extract (Camellia sinesis). She denied history of liver disease, alcohol use, and risk factors for viral hepatitis. On examination, she was jaundiced but had no fever or rash. Laboratory tests showed a serum bilirubin of 11.7 mg/dL and marked elevations in serum aminotransferase levels (~20 times ULN) with minimal increases in alkaline phosphatase (Table). Tests for hepatitis A, B and C were negative as were autoantibodies, except for antinuclear antibody which was weakly positive (1:40, speckled pattern). Liver biopsy revealed marked interface necrosis and inflammation and mild lobular inflammation. Cholecystectomy and intraoperative cholangiography were performed. The patient began to improve rapidly and was discharged after two weeks in the hospital. One month later, liver tests had improved significantly. One year later, she was again admitted with a one week history of abdominal pain and jaundice. She admitted to resuming The Right Approach Complex one month earlier, but stopped taking it one week before presentation when she developed dysphagia. On admission, she was jaundiced. She again improved rapidly and six months later all liver tests were normal.

#### Key Points

Medication: | The Right Choice (383.3 mg Camellia sinensis extract per 3 capsules)
Pattern: | Hepatocellular
Severity: | 3+
Latency: | 4 months initially, 1 month on reexposure
Recovery: | 1 month
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Started The Right Approach (~1 gram of green tea extract daily)
16 weeks | 0 | 1788 | 1783 | 238 | 11.7 | Liver biopsy, interface necrosis and lobular inflammation
18 weeks | 2 weeks | 92 | 79 | - | 1.9
| | Restarted The Right Approach 1 year later
4 weeks | 0 | 1131 | 977 | 165 | 11.7 | INR: 1.3
5 weeks | 1 week | 877 | 816 | 165 | 2.9
2 months | 5 weeks | 69 | 80 | - | 1.2
7 months | 6 months | 25 | 27 | | 1.0
Normal Values | | <35 | <35 | <130 | <1.2

#### Comment

This case demonstrates the typical acute viral hepatitis like presentation of green tea hepatotoxicity with jaundice, accompanied by marked elevations in serum aminotransferase levels and minimal increases in alkaline phosphatase. Recurrence with a similar pattern of liver injury upon reexposure to the same product provided clear evidence of a causal association. Green tea extract was the major ingredient of the supplement and its other components have not been reported to cause liver injury (calcium, chromium, magnolia extract, epimedium extract, banaba leaf extract, β-sitosterol and vanadium). The hepatotoxicity of herbal products has become an increasing problem with the increasing use of these agents. Interestingly, the liver injury is usually hepatocellular and resembles acute viral hepatitis.

### Case 4. Acute hepatitis and jaundice after disulfiram in an alcoholic patient with chronic hepatitis C.(4)

[DILIN Case #105-0050]

A 42 year old male with chronic hepatitis C was started on disulfiram (Anabuse) for chronic alcohol abuse and lisinopril for hypertension. A few days later he developed diarrhea and stopped lisinopril. One to two weeks later he developed fatigue, nausea, vomiting and poor appetite, but he continued taking disulfiram until he developed jaundice 30 days after starting. He sought medical attention 2 days later and was hospitalized for evaluation. He had a history of type 2 diabetes for which he had been taking metformin for several years. He claimed to have had no alcohol intake since starting Antabuse and admission serum alcohol level was negative. His chronic hepatitis C (genotype 1, HCV RNA 32,300 IU/mL) was considered mild and had never been treated. Physical examination showed no fever, rash or signs of chronic liver disease. He was mildly jaundiced. Laboratory tests revealed a total serum bilirubin of 5.9 mg/dL with marked elevations in ALT (1715 U/L) and AST (919 U/L), but normal alkaline phosphatase levels (95 U/L). Tests for hepatitis A and B were negative as were autoantibodies. An abdominal ultrasound showed a normal liver texture and no evidence of biliary obstruction which was confirmed by magnetic resonance cholangiography. Over the next few days, he began to improve and serum bilirubin was normal one week later. In follow up, his symptoms resolved and serum ALT levels fell to baseline values. Importantly, HCV RNA was undetectable during the acute injury, but reappeared once it had resolved. One year after this episode, he again had detectable serum HCV RNA and ALT levels were mildly elevated. He was subsequently treated with a course of peginterferon and ribavirin and achieved a sustained virological response. In recent follow up, he has had normal serum aminotransferase levels and no detectable HCV RNA.

#### Key Points

Medication: | Disulfiram (100 mg daily)
Pattern: | Hepatocellular (R=41)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 32 days
Recovery: | Uncertain timing
Other medications: | Metformin (3 years), lisinopril (for 1 week, 3 weeks before presentation)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 49 | 52 | 0.9
5 days | 0 | Fatigue, nausea, anorexia
30 days | 0 | Jaundice, disulfiram stopped
32 days | 2 days | 1715 | 95 | 5.9
33 days | 3 days | 1305 | 93 | 5.1 | HCV RNA negative
35 days | 5 days | 1238 | 137 | 5.6
40 days | 10 days | 562 | 109 | 2.0
41 days | 11 days | 406 | 98 | 1.6
1 year | 1 year | 59 | 83 | 0.3 | HCV RNA 385,000 IU/mL
| | Treated with peginterferon and ribavirin with sustained virological response
4 years | 4 years | 26 | 97 | 0.8 | HCV RNA negative
Normal Values | | <42 | <115 | <1.2

#### Comment

Despite having chronic hepatitis C and alcoholism, the acute injury that began within a month of starting disulfiram was clearly due to this medication rather than HCV or alcoholic hepatic injury. Disulfiram typically causes an acute hepatitis like syndrome 2 to 12 weeks after starting the medication that can be severe and lead to acute liver failure or need for liver transplantation. Alcoholic liver injury can cause jaundice and symptoms, but rarely causes serum aminotransferase elevations above 5 to 8 times the upper limit of normal and AST values are usually higher than ALT values. Chronic hepatitis C can be associated with flares of disease activity, but these are rarely associated with symptoms or jaundice unless cirrhosis is present. Importantly, HCV RNA levels usually increase or are stable during flares of hepatitis C but fall markedly (and may be below the level of detection) during acute superimposed forms of liver injury.

## CITED REFERENCES

1 DILIN Case #102-0056.
2 Rigal J, Furet Y, Autret E, Breteau M. [Severe mixed hepatitis caused by fenofibrate? A review of the literature apropos of a case]. Rev Med Interne 1989; 10: 65-7. 2655052
3 Bonkovsky HL. Hepatotoxicity associated with supplements containing Chinese green tea (Camellia sinensis). Ann Intern Med 2006; 144: 68-71. 16389263
4 DILIN Case #105-0050.

## HEPATIC HISTOLOGY OF ACUTE HEPATITIS

Histologically, acute hepatitis is charactized by diffuse parenchymal injury. The hepatocytes may show cell swelling or apoptosis and in most cases there are numerous small foci of lobular inflammation. The inflammation may consist of any combination of lymphocytes, macrophages and plasma cells. Portal inflammation may be present, but is not necessary. Lobular disarray results when there is disruption of the sinusoidal architecture by cell injury and inflammation. Hepatocyte rosettes and mitotic figures may be seen as evidence of liver regeneration. Cholestasis in the form of visible bile in canaliculi and hepatocyte cytoplasm is sometimes seen in acinar zone 3. When the cholestasis is prominent compared to the inflammation, the case should be classified as cholestatic hepatitis rather than acute hepatitis. In severe cases there may be multiacinar or bridging necrosis and these changes can lead to submassive or massive hepatic necrosis and hepatic failure. Mild cases may show only foci of lobular inflammation or hepatocyte apoptosis. The presence of significant fibrosis (more than portal fibrotic expansion) should suggest acute hepatitis superimposed on chronic hepatitis. Cases that are in a resolving phase will often show only clusters of pigmented macrophages in the parenchyma and portal areas.

## Histologic Images

Photomicrographs by

David E. Kleiner, MD, PhD

Laboratory of Pathology

National Cancer Institute

(See high resolution images)

Case A. Acute Hepatitis Ascribed to Green Tea Containing Herbal Product

Histologic Features to Note:

Acute hepatitis with zone 3 necrosis. There is a loss of the hepatocytes around the hepatic vein (V), but unlike cases of acute hepatic necrosis, there is abundant lymphocytic inflammation within and around the area of necrosis.

(See high resolution image)

Case A. Acute Hepatitis Ascribed to Green Tea Containing Herbal Product. Acute hepatitis with zone 3 necrosis.

Case A. Acute Hepatitis Ascribed to Green Tea (continued)

Histologic Features to Note:

There is a loss of hepatocytes between the portal area (P) and the vein (V), a change known as bridging necrosis.

(See high resolution image)

Case A. Acute Hepatitis Ascribed to Green Tea (continued). There is a loss of hepatocytes between the portal area (P) and the vein (V), a change known as bridging necrosis.

Case B. Acute Hepatitis Probably Due to Azithromycin

Histologic Features to Note:

There are apoptotic hepatocytes (arrows) and many small foci of lymphocytic inflammation associated with loss of sinusoidal architecture (lobular disarray).

(See high resolution image)

Case B. Acute Hepatitis Probably Due to Azithromycin. There are apoptotic hepatocytes (arrows) and many small foci of lymphocytic inflammation associated with loss of sinusoidal architecture (lobular disarray).

Case C. Acute Hepatitis Due to Etanercept

Histologic Features to Note:

There is lobular disarray with hepatocyte regeneration. The inflammation is not marked, but scattered foci of lymphocytic infiltration are present.

(See high resolution image)

Case C. Acute Hepatitis Due to Etanercept. There is lobular disarray with hepatocyte regeneration.

Case C. Acute Hepatitis Due to Etanercept (continued)

Histologic Features to Note:

At higher magnification there are many hepatocyte rosettes (fat arrows) and a few apoptotic hepatocytes (thin arrows).

(See high resolution image)

Case C. Acute Hepatitis Due to Etanercept (continued). At higher magnification there are many hepatocyte rosettes (fat arrows) and a few apoptotic hepatocytes (thin arrows).

Case D. Acute Hepatitis Due to Isoniazid

Histologic Features to Note:

There is marked inflammation with hepatocyte rosette formation and lobular disarray. There is also an area of confluent necrosis (N) with pigmented macrophages.

(See high resolution image)

Case D. Acute Hepatitis Due to Isoniazid. There is marked inflammation with hepatocyte rosette formation and lobular disarray.

Case D. Acute Hepatitis Due to Isoniazid (continued)

Histologic Features to Note:

This photo shows a portal area on the left and the hepatocellular parenchyma on the right. The hepatocyte interface is obscured by inflammation.

(See high resolution image)

Case D. Acute Hepatitis Due to Isoniazid (continued). This photo shows a portal area on the left and the hepatocellular parenchyma on the right.